# Ifosfamide

## OVERVIEW

### Introduction

Ifosfamide is a parenterally administered alkylating agent similar to cyclophosphamide that is used in the treatment of several forms of cancer including lymphomas, sarcoma and advanced forms of solid organ cancer such as breast, testicular, ovarian, gastric and lung cancer. Ifosfamide therapy is associated with minor transient serum enzyme elevations and has been linked to cases of acute liver injury, including acute cholestatic hepatitis and veno-occlusive disease.

### Background

Ifosfamide (eye fos' fa mide) is an analogue of cyclophosphamide and thus a nitrogen mustard-like alkylating agent that is used in the therapy of several forms of leukemia, lymphoma and solid organ cancer. Like cyclophosphamide, ifosfamide requires activation in the liver to form its active intermediaries which act by modifying and cross linking purine bases in DNA, thus inhibiting DNA, RNA and protein synthesis and leading to programmed cell death (apoptosis) in rapidly dividing cells. Ifosfamide was approved for use in the United States in 1988 and its major indication is for germ cell testicular cancer, but it is also used in combination with other agents in the treatment of breast, lung, bladder, cervical, and ovarian cancer, Hodgkin's and non-Hodgkin’s lymphoma, and soft tissue and osteogenic sarcomas. Ifosfamide is given intravenously and is available in liquid formulations (1 and 3 gram vials), generically and under the trade name Ifex. Recommended doses vary by body weight and malignant condition. Common side effects include alopecia, nausea, vomiting, diarrhea, gastrointestinal upset, cystitis, oral ulcers and bone marrow suppression. It is commonly given with mesna to reduce the risk of hemorrhagic cystitis.

### Hepatotoxicity

The toxicity of ifosfamide seems to be similar to that of cyclophosphamide. Mild and transient elevations in serum aminotransferase levels are found in a high proportion of patients receiving ifosfamide. Because ifosfamide is typically given in combination with other antineoplastic agents, its role in causing the serum enzyme elevations is often not clear. The abnormalities are generally transient, do not cause symptoms and do not require dose modification. Clinically apparent liver injury from ifosfamide has been limited to a small number of cases of cholestatic hepatitis arising within a few weeks of receiving ifosfamide (with other antineoplastic agents). In addition, sinusoidal obstruction syndrome has been reported after conditioning regimens that have included ifosfamide in preparation for hematopoietic cell transplantation. The onset of injury is usually within one to three weeks of the myeloablation and is characterized by a sudden onset of abdominal pain, weight gain, ascites, marked increase in serum aminotransferase levels (and lactic dehydrogenase), and subsequent jaundice and hepatic dysfunction. The severity of sinusoidal obstruction syndrome varies from a transient, self limited injury to acute liver failure. The diagnosis is usually based on clinical features of tenderness and enlargement of the liver, weight gain, ascites and jaundice. Liver biopsy is diagnostic but often contraindicated, because of severe thrombocytopenia after bone marrow transplantation.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of idiosyncratic hepatotoxicity from ifosfamide is not known. The sinusoidal obstruction syndrome induced by ifosfamide is probably related to the direct toxic effect of ifosfamide on sinusoidal cells in the liver, causing their necrosis and release into the sinusoids, obstruction and obliteration of hepatic veins. Ifosfamide is extensively metabolized by hepatic cytochrome P450 system and more than 150 metabolites have been identified, but their pharmacokinetics and toxicities are not well defined.

### Outcome and Management

The severity of liver injury ranges from mild elevations in liver enzymes to massive, fatal hepatic necrosis due to sinusoidal obstruction syndrome. There is currently no specific therapy for veno-occlusive disease other than supportive management and avoidance of further damage. Rechallenge should be avoided.

Drug Class: Antineoplastic Agents, Alkylating Agents, see also Cyclophosphamide

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Ifosfamide – Generic, Ifex®

DRUG CLASS

Antineoplastic Agents, Alkylating Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Ifosfamide)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Ifosfamide | 3778-73-2 | C7-H15-Cl2-N2-O2-P | Ifosfamide Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 15 April 2018.

Zimmerman HJ. Oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 673-708. (Expert review of hepatotoxicity of cancer chemotherapeutic agents published in 1999; mentions a report of two cases of cholestatic injury in patients receiving both ifosfamide and etoposide [Paschke 1988]).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 551. (Review of hepatotoxicity of cancer chemotherapeutic agents mentions that cyclophosphamide is an uncommon cause of liver injury, but in high doses in combination with busulfan or irradiation, can cause sinusoidal obstruction syndrome; ifosfamide is not separately discussed).
Chabner BA, Bertino J, Cleary J, Ortiz T, Lane A, Supko JG, Ryan D. Cytotoxic agents. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1677-730. (Textbook of pharmacology and therapeutics: ifosfamide is a analogue of cyclophosphamide that is given intravenously and is a common component of high dose chemotherapy regimens with hematopoietic cell transplantation).
Paschke R, Worst P, Brust J, Queisser W. [Hepatotoxicity with etoposide-ifosfamide combination therapy]. Onkologie 1988; 11: 273-5. German. (Two patients treated for bronchogenic carcinoma; 57 year old man developed liver injury [bilirubin 2.7 rising to 22.6 mg/dL, AST 27 U/L, Alk P 225 U/L] 10 days after receiving etoposide and isofosfamide; 68 year old woman developed jaundice after a third course of etiopsomide with ifosfamide [bilirubin 6.5 rising to 12.3 mg/dL, AST 39 U/L, Alk P 218 U/L]). 2853857
Cheung MC, Jones RL, Judson I. Acute liver toxicity with ifosfamide in the treatment of sarcoma: a case report. J Med Case Rep 2011; 5: 180. (61 year old woman with inoperable synovial sarcoma developed confusion 3 days after completing chemotherapy with doxorubicin, dexamethasone and ifosfamide [bilirubin 2.1 mg/dL, ALT 3086 U/L, Alk P 77 U/L, INR 2,2, ammonia 77 µ M/L] recovering within two weeks and later tolerating doxorubicin without recurrence). 21569511
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/24552865) (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, one of which was attributed to cyclophosphamide but none to ifosfamide).
Douros A, Bronder E, Andersohn F, Klimpel A, Thomae M, Sarganas G, Kreutz R, et al. Drug-induced liver injury: results from the hospital-based Berlin Case-Control Surveillance Study. Br J Clin Pharmacol 2015; 79: 988-99. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/25444550) (Among 198 patients with suspected drug induced liver injury enrolled in a case control surveillance study involving 51 hospitals in Berlin between 2002 and 2011, one case was considered probably due to cyclophosphamide but none to ifosfamide).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/25754159) (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 49 cases [6%] were attributed to antineoplastic agents, 2 of which were due to cyclophosphamide but none to ifosfamide).
Fan XL, Cai GP, Zhu LL, Ding GM. Efficacy and safety of ifosfamide-based chemotherapy for osteosarcoma: a meta-analysis. Drug Des Devel Ther 2015; 9: 5925-32. (Systematic review of literature on use of ifosfamide for osteosarcoma concluded that it significantly improved event-free survival while adverse reactions included fever, nausea, cardiotoxicity, CNS toxicity, skin rash and myelosuppression; no mention of ALT elevations or hepatotoxicity). 26604690

## OTHER REFERENCE LINKS

1. Recent References on Ifosfamide: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Ifosfamide/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Ifosfamide: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Ifosfamide)